# Tolcapone

## OVERVIEW

### Introduction

Tolcapone is a catechol-O-methyltransferase inhibitor used in the therapy of Parkinson disease as adjunctive therapy in combination with levodopa and carbidopa. Tolcapone has been associated with serum enzyme elevations during treatment and with several instances of clinically apparent acute liver injury, which can be severe and even fatal.

### Background

Tolcapone (tol' ka pone) is a specific inhibitor of cathechol-O-methyltransferase (COMT), which is a major enzyme in the pathway of levodopa metabolism. As a result, tolcapone slows the metabolism of levodopa and results in an increase in its bioavailability and duration of action. Tolcapone inhibits COMT activity both peripherally and in the central nervous system. Tolcapone was approved for use in the United States in 1998 for the therapy of symptomatic Parkinson disease as an adjunct to levodopa/carbidopa therapy in patients with motor complications. Soon after its approval, it was withdrawn after several instances of acute liver failure were attributed to its use. Subsequently tolcapone was reintroduced, but with requirements for informing patients about the possibility of liver injury and rigorous monitoring of serum enzymes during treatment. Tolcapone is recommended only for patients who fail to respond to other conventional adjunctive therapies in patients who experience episodes of motor abnormalities (“off” episodes) while receiving levodopa therapy. Two other COMT inhibitors have been approved that have not been associated with liver injury, and tolcapone is now rarely used. Tolcapone remains available in tablets of 100 mg generically and under the brand name of Tasmar. Tolcapone is typically initiated in doses of 100 mg three times daily, with adjustment upwards based upon tolerance and clinical effects to a maximum of 600 mg daily. Common side effects include somnolence, dizziness, confusion, dyskinesia, vivid dreams, hallucinations, depression, fatigue, headache, diarrhea and gastrointestinal upset, symptoms that are typical of dopaminergic stimulation and enhanced effects of levodopa. Severe adverse events can include hypotension, syncope, psychotic behaviors, poor impulse control, hallucinations, diarrhea, colitis, rhabdomyolysis, and severe hepatotoxicity.

### Hepatotoxicity

Tolcapone has been reported to cause serum aminotransferase elevations above 3 times the upper limit of normal in 1% to 5% of patients. While these abnormalities are usually asymptomatic and self-limiting, some persist if therapy is continued and resolved only with stopping tolcapone. More importantly, tolcapone has been implicated in several cases of severe, clinically apparent acute liver injury and at least three cases of death from acute liver failure. The onset of injury was insidious, arising 1 to 5 months after starting treatment. The pattern of serum enzyme elevations was hepatocellular and the clinical phenotype was similar to acute viral hepatitis. Immunoallergic manifestations were not present, but some patients had autoantibodies of unclear significance. Because of these reports, regular monitoring of serum aminotransferase levels has been mandated (every 2 to 4 weeks for the first 6 months of treatment and as clinically indicated thereafter) during tolcapone therapy, and treatment should be promptly discontinued if ALT or AST levels rise above twice the upper limit of the normal range or if signs or symptoms of liver injury are present.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

Tolcapone is metabolized extensively in the liver and undergoes glucuronidation prior to excretion. The hepatotoxicity of tolcapone is likely due to production of a toxic intermediate that overwhelms the usual protective mechanisms of excretion. Increased likelihood of hepatic injury due to tolcapone has been linked to variants of the gene that is responsible for glucuronidation, UDP-glucuronosyl transferase.

### Outcome and Management

Liver injury caused by tolcapone ranges from mild, transient and asymptomatic serum enzyme elevations to clinically apparent hepatitis and acute liver failure. Tolcapone therapy has not been associated with chronic hepatitis or vanishing bile duct syndrome. Therapy of acute liver failure due to medications is largely supportive, but infusions of n-acetyl cysteine may be beneficial if given early. In at least one case report of acute liver failure due to tolcapone, autoimmune features led to the use of corticosteroids which appeared to be beneficial. Because of the propensity for tolcapone to cause acute liver failure, routine testing for serum aminotransferase levels should be done every 2 to 4 weeks for 6 months after initiation of therapy and as clinically indicated thereafter. Tolcapone should be discontinued if ALT or AST levels rise above twice the upper limit of the normal range or if any signs and symptoms suggestive of liver injury appear. There does not appear to be cross sensitivity to hepatic injury between tolcapone and entacapone, a COMT inhibitor with a similar chemical structure.

Drug Class: Parkinson Disease Agents

Other Drugs in the Subclass, COMT Inhibitors: Entacapone, Opicapone

## CASE REPORT

### Case 1. Acute liver failure attributed to tolcapone.(1-3)

A 74 year old woman with Parkinson disease developed jaundice 8 weeks after being switched from amantadine to tolcapone (100 mg twice daily), because of motor fluctuations during long term levodopa therapy. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. She had suffered from Parkinson disease for more than 15 years and was maintained on levodopa and benserazide (25 mg three times daily: a decarboxylase inhibitor similar to carbidopa). Other medications included etilefrine (30 mg daily: an oral adrenergic sympathomimetic amine) for orthostatic hypotension, amiloride (2.5 mg) combined with hydrochlorothiazine (25 mg) twice weekly for edema, and oxazepam (15 mg) at bedtime for sleep, all of these medications having been taken chronically. She had normal liver test results on several occasions in the past while taking these medications. On presentation with jaundice, she was confused and was considered to have stage 2 hepatic encephalopathy. Her resting tremor, akinesia and rigidity were unchanged from before. Laboratory test results showed bilirubin elevations (total 21.5 mg/dL) and marked increases in serum aminotransferase levels (ALT 2904 U/L, AST 2541 U/L), with minimal abnormality in alkaline phosphatase levels (177 U/L) (Table). The prothrombin time was prolonged (21 seconds; INR 1.7) and ammonia levels were elevated (102 µmol/L). Tests for hepatitis A, B and C were negative and abdominal ultrasound showed no evidence of biliary obstruction or tumor. A transjugular liver biopsy showed large areas of parenchymal collapse that was predominantly centrolobular (zone 3) and accompanied by dense infiltration with chronic inflammatory cells (including eosinophils). There was marked cholestasis, but normal numbers of uninjured bile ducts. There was no fibrosis. The hepatic venous pressure gradient was 7.5 mm Hg (normal <6). Tolcapone was discontinued on admission, but she continued to deteriorate with steadily rising bilirubin levels and worsening consciousness, and she died 13 days later.

#### Key Points

Medication: | Tolcapone (200 mg daily)
Pattern: | Hepatocellular (R=~80)
Severity: | 5+ (death within 2 weeks from acute liver failure)
Latency: | 2 months
Recovery: | None
Other medications: | Levodopa, benserazide, etilefrine, amiloride/hydrochlorothiazide, oxazepam

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
-1 year | | 21 | | | 1 year before starting
2 months | 0 | 2904 | 117 | 21.4 | Admission
| 1 day | 2810 | | 24.8 | Liver biopsy
| 2 days | 2625 | | 29.8 | Worsening coma
| 3 days | 2710 | | 39.2
| 4 days | 2150 | | 35.4
| 5 days | 2275 | | 42.4
| 6 days | 1905 | | 35.6
| 7 days | 1930 | | 40.9
| 8 days | 1783
2.5 months | 2 weeks | Patient died of hepatic failure
Normal Values | | <36 | <125 | <1.2

* Some values estimated from Figure 2.

#### Comment

This was the first case report in the literature of acute liver failure attributed to tolcapone. The case was published initially as a letter to the editor (Assal: 1998), then as a full case report with details of hepatic histology (Spahr: 2000), and then summarized with 3 other cases of acute liver failure in support of guidelines for monitoring patients on tolcapone (Olanow: 2000). The timing of onset, severe hepatocellular injury and exclusion of other causes of acute liver disease supported the diagnosis of tolcapone induced acute liver injury. Subsequently, routine monitoring for serum enzyme levels during tolcapone therapy was not only recommended, but mandated by the US Food and Drug Administration and no further cases of acute liver failure have been published. However, the concern over hepatotoxicity and the requirement for monitoring has led to a limited use of this medication. Because it appears to be more effective than other COMT inhibitors and can have a beneficial effect in advanced Parkinson disease, it has been reintroduced with strict guidelines for monitoring.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tolcapone – Generic, Tasmar®

DRUG CLASS

Parkinson Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tolcapone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tolcapone | 134308-13-7 | C14-H11-N-O5

## CITED REFERENCES

1 Assal F, Spahr L, Hadengue A, Rubbia-Brandt L, Burkhard PR. (1998). Tolcapone and fulminant hepatitis. Lancet.
2 Spahr L, Rubbia-Brandt L, Burkhard PR, Assal F, Hadengue A. (2000). Tolcapone-related fulminant hepatitis: electron microscopy shows mitochondrial alterations. Dig Dis Sci.
3 Olanow CW. (2000). Tolcapone and hepatotoxic effects. Tasmar Advisory Panel Arch Neurol.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 October 2021

Abbreviations used: COMT, catechol O-methyltransferase; MAO, monoamine oxidase.

Zimmerman HJ. Antiparkinsonism drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 715-7. (Expert review of hepatotoxicity published in 1999; among anticholinergic agents, "only trihexyphenidyl has been incriminated in hepatic injury"; other antiparkinsonism drugs discussed include levodopa, lergotrile [no longer available], pergolide and bromocriptine, but not tolcapone).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier Inc, 2013, pp. 443-62. (Review of hepatotoxicity of agents acting on the central nervous system).
Roberson ED. Parkinson Disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 328-333. (Textbook of pharmacology and therapeutics; istradefylline and adenosine receptor antagonists are not discussed).
Waters CH, Kurth M, Bailey P, Shulman LM, LeWitt P, Dorflinger E, Deptula D. (1998). S. Tolcapone in stable Parkinson's disease: efficacy and safety of long-term treatment. Tolcapone Stable Study Group. Neurology. (Among 298 patients with stable Parkinson disease treated with levodopa and either tolcapone [n=196] or placebo [n=102], ALT abnormalities occurred in 3-5% of tolcapone treated patients between month 1 and 6 of therapy, 4 were withdrawn and recovered; abnormalities resolved in another 4 despite continuing on therapy).
Hauser RA, Molho E, Shale H, Pedder S, Dorflinger EE. (1998). A pilot evaluation of the tolerability, safety, and efficacy of tolcapone alone and in combination with oral selegiline in untreated Parkinson's disease patients. Tolcapone De Novo Study Group. Mov Disord. (Among 83 patients with Parkinson disease treated with tolcapone with or without selegiline for 8 weeks, ALT elevations occurred in 1 patient [2%] on tolcapone alone).
Tolcapone for Parkinson's disease. (1998). Med Lett Drugs Ther. (Concise summary of clinical efficacy and safety of tolcapone shortly after its approval in the US; common side effects were diarrhea, increase in levodopa related [dopaminergic] side effects and serum ALT elevations).
Assal F, Spahr L, Hadengue A, Rubbia-Brandt L, Burkhard PR. (1998). Tolcapone and fulminant hepatitis. Lancet. (74 year old woman with Parkinson disease developed jaundice 9 weeks after starting tolcapone [bilirubin 17.1 mg/dL, ALT 2904 U/L, Alk P 177 U/L, protime 21 sec], progressing to hepatic failure and death 2 weeks later).
Rivest J, Barclay CL, Suchowersky O. (1999). COMT inhibitors in Parkinson's disease. Can J Neurol Sci. (Review of efficacy and safety of tolcapone and entacapone in Parkinson disease; ALT elevations above 3 times the ULN occurred in 2-5% of tolcapone, but in no entacapone recipients; reports of 3 cases of acute liver failure due to tolcapone led to its withdrawal in several countries).
Kaakkola S. (2000). Clinical pharmacology, therapeutic use and potential of COMT inhibitors in Parkinson's disease. Drugs. (Review of the mechanism of action, pharmacology, efficacy and side effects of tolcapone and entacapone; both enhance dopaminergic effects of levodopa and diarrhea is a frequent dose modifying side effect; hepatotoxicity occurs with tolcapone, but has not been reported with entacapone).
Lambert D, Waters CH. (2000). Comparative tolerability of the newer generation antiparkinsonian agents. Drugs Aging. (Review of mechanism of action, tolerability and safety of selegiline, pramipexole, ropinirole, tolcapone and entacapone in Parkinson disease).
Olanow CW. (2000). Tolcapone and hepatotoxic effects. Tasmar Advisory Panel. Arch Neurol. (Consensus recommendations for monitoring patients on tolcapone after 4 reports of acute liver failure; among 1535 patients treated in phase III studies, ALT or AST elevations [>3 times ULN] occurred in 1.3-3.7% of patients, returning to normal when discontinued and one woman developed jaundice and died; postmarketing reports included 4 patients, ages 66 to 74, with onset of symptoms and jaundice after 2-4 months, [bilirubin 6.9-26.1 mg/dL, ALT 1245-5020 U/L, Alk P 66-347 U/L], 3 died within 1-2 weeks of presentation).
Spahr L, Rubbia-Brandt L, Burkhard PR, Assal F, Hadengue A. (2000). Tolcapone-related fulminant hepatitis: electron microscopy shows mitochondrial alterations. Dig Dis Sci. (Histologic analysis of patient with acute liver failure due to tolcapone [Assal 1988], showed multilobular collapse, inflammatory infiltrates including eosinophils, cholestasis, and focal microvescular steatosis; electron microscopy suggested mitochondrial injury: Case 1).
Watkins P. (2000). COMT inhibitors and liver toxicity. Neurology. (Review of hepatotoxicity of tolcapone and entacapone suggesting that liver injury is not a class effect and that there have been no reports of jaundice attributed to entacapone).
Entacapone for Parkinson's disease. (2000). Med Lett Drugs Ther. (Concise summary of clinical efficacy and safety of entacapone shortly after its approval in the US; common side effects were diarrhea, increase in levodopa related side effects, but no reported hepatotoxicity as occurs with tolcapone).
Blum MW, Siegel AM, Meier R, Hess K. (2001). Neuroleptic malignant-like syndrome and acute hepatitis during tolcapone and clozapine medication. Eur Neurol. (70 year old woman developed stupor, rigidity and hyperthermia with increases in CPK [3132 U/L] and ALT [988 U/L], but not bilirubin or alkaline phosphatase while on the combination of tolcapone and clozapine, resolving rapidly on stopping therapy; compatible with neuroleptic malignant-like syndrome).
Myllylä VV, Kultalahti ER, Haapaniemi H, Leinonen M, FILOMEN Study Group. (2001). Twelve-month safety of entacapone in patients with Parkinson's disease. Eur J Neurol. (Among 326 patients with Parkinson disease treated with entacapone or placebo, ALT elevations occurred in 6.9% on drug vs 4.6% on placebo and were above 3 times ULN in 0.9% vs 0.0%; no patient developed clinically apparent liver injury that could be attributed to entacapone).
Acuña G, Foernzler D, Leong D, Rabbia M, Smit R, Dorflinger E, Gasser R, et al. (2002). Pharmacogenetic analysis of adverse drug effect reveals genetic variant for susceptibility to liver toxicity. Pharmacogenomics J. (DNA genotyping of 30 single nucleotide polymorphisms in 135 patients who had liver enzyme elevations during tolcapone therapy and controls found variants within the UDP-glucuronsyl transferase gene that were associated with liver injury).
Fisher A, Croft-Baker J, Davis M, Purcell P, McLean AJ. (2002). Entacapone-induced hepatotoxicity and hepatic dysfunction. Mov Disord. (Three cases of clinically apparent liver injury attributed to entacapone use; 74 year old woman developed nausea and fatigue 2 weeks after adding entacapone to a regimen of levodopa/benserazide for Parkinson disease [bilirubin 2.4 mg/dL, ALT 104 U/L, Alk P 238 U/L], with rapid improvement on stopping; 2 other cases were reported to Australian Drug Reaction Database with only partial documentation, arising 5 and 6 weeks after starting entacapone, with cholestatic liver enzyme elevations and mild jaundice).
Benabou R, Waters C. (2003). Hepatotoxic profile of catechol-O-methyltransferase inhibitors in Parkinson's disease. Expert Opin Drug Saf. (Review of hepatotoxicity of tolcapone and entacapone).
Borges N. (2003). Tolcapone-related liver dysfunction: implications for use in Parkinson's disease therapy. Drug Saf. (Review of hepatotoxicity of tolcapone and possible mechanisms).
Brooks DJ. (2004). Safety and tolerability of COMT inhibitors. Neurology. (Review of safety and side effects of entacapone; in phase III trials ALT elevations >3 times ULN occurred in 0.3-0.5% of patients taking entacapone and 0.4% on placebo, and there were no cases of jaundice or clinically apparent liver injury among ~1600 entacapone treated patients).
Deane KH, Spieker S, Clarke CE. (2004). Catechol-O-methyltransferase inhibitors for levodopa-induced complications in Parkinson's disease. Cochrane Database Syst Rev. (Systematic review of efficacy of tolcapone and entacapone; ALT elevations reported in variable proportions of patients on tolcapone).
(2005). Levodopa + carbidopa + entacapone. Entacapone: a second look: new preparations. Parkinson's disease: a modest effect. Prescrire Int. (Review of risks and benefits of a fixed dose combination of levodopa, carbidopa and entacapone mentions that entacapone may cause cholestatic hepatitis and that is has not been shown to be more effective than bromocriptine).
Borges N. (2005). Tolcapone in Parkinson's disease: liver toxicity and clinical efficacy. Expert Opin Drug Saf. (Review of hepatotoxicity of tolcapone and its possible mechanisms).
Korri H, Awada A. (2005). Rev Neurol (Paris). (61 year old man with Parkinson disease developed jaundice and fever 17 months after starting tolcapone [bilirubin 3.1 mg/dL, ALT 399 U/L, Alk P 115 U/L], resolving upon stopping).
Martignoni E, Cosentino M, Ferrari M, Porta G, Mattarucchi E, Marino F, Lecchini S, et al. (2005). Two patients with COMT inhibitor-induced hepatic dysfunction and UGT1A9 genetic polymorphism. Neurology. (Two patients who had ALT elevations [78 and 284 U/L] during tolcapone therapy, one of whom had similar elevations during entacapone treatment; both had the A(T)9AT sequence [1A9*1] in the promoter of the UGT1A9 gene).
(2006). Tolcapone: new drug. In Parkinson's disease: unacceptable risk of severe hepatitis. Prescrire Int. (Review of tolcapone as adjunctive therapy in Parkinson disease suggests that the hepatotoxicity risk makes it an unacceptable option).
Leegwater-Kim J, Waters C. (2006). Tolcapone in the management of Parkinson's disease. Expert Opin Pharmacother. (Review on use of tolcapone in Parkinson disease suggesting that with proper monitoring, the potential for hepatotoxicity is "negligibly small").
Stocchi F, De Pandis MF. (2006). Utility of tolcapone in fluctuating Parkinson's disease. Clin Interv Aging. (Review of role of tolcapone in treatment of Parkinson disease, indicating its efficacy in patients with fluctuating symptoms and its safety with proper monitoring of serum enzymes).
Entacapone to Tolcapone Switch Study Investigators. (2007). Entacapone to tolcapone switch: Multicenter double-blind, randomized, active-controlled trial in advanced Parkinson's disease. Mov Disord. (Randomized controlled trial of replacing entacapone with tolcapone in patients with Parkinson disease and motor fluctuations on long term levodopa therapy; ALT elevations occurred in 3% on entacapone and 9% on tolcapone, but were mild and self-limiting).
Leegwater-Kim J, Waters C. (2007). Role of tolcapone in the treatment of Parkinson's disease. Expert Rev Neurother. (Review of the pharmacology, metabolism, clinical efficacy and safety of tolcapone, indicating that the risk of hepatotoxicity "is very small if proper hepatic monitoring guidelines are followed").
Olanow CW, Watkins PB. (2007). Tolcapone: an efficacy and safety review (2007). Clin Neuropharmacol. (Review of the efficacy and safety of tolcapone focusing upon the hepatotoxicity concludes that tolcapone can be used safety if there is strict adherence to routine liver test monitoring requirements of every 2-4 weeks for 6 months and at 3-6 month intervals thereafter).
Lees AJ, Ratziu V, Tolosa E, Oertel WH. (2007). Safety and tolerability of adjunctive tolcapone treatment in patients with early Parkinson's disease. J Neurol Neurosurg Psychiatry. (Controlled trial of tolcapone vs placebo combined with levodopa and carbidopa in 677 patients with early Parkinson disease; ALT or AST elevations occurred in 20% of placebo- vs 27% of tolcapone treated patients and were >3 times ULN in 1.2% [placebo] vs 1.8% [tolcapone], almost all during first 6 months; 1% of tolcapone treated patients stopped because of ALT elevations, but none developed jaundice or clinically apparent liver injury).
Lew MF, Kricorian G. (2007). Results from a 2-year centralized tolcapone liver enzyme monitoring program. Clin Neuropharmacol. (Centralized testing for ALT and AST in 1725 patients with Parkinson disease treated with tolcapone for up to 2 years; 69 [3.9%] had at least one elevation, but <1% had an elevation above 2 times the ULN and most returned to normal despite continuing therapy).
(2008). Entacapone: hepatitis (continued). The risk of liver damage is being confirmed. It is better not to expose parkinsonian patients to this drug. Prescrire Int. (Commentary mentions that the European Medicines Agency has reported 29 cases of hepatic disorders linked to entacapone).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver injury in the US collected between 2004 and 2008, none were due to drugs used for Parkinson disease).
Canesi M, Zecchinelli AL, Pezzoli G, Antonini A. (2008). Clinical experience of tolcapone in advanced Parkinson's disease. Neurol Sci. (Among 66 patients with advanced Parkinson disease treated with tolcapone, 2 [3%] were withdrawn from therapy because of ALT elevations).
Brooks DJ, Leinonen M, Kuoppamäki M, Nissinen H. (2008). Five-year efficacy and safety of levodopa/DDCI and entacapone in patients with Parkinson's disease. J Neural Transm. (Retrospective, pooled analysis of 5 controlled trials with 5 year extension phases that included 806 patients with Parkinson disease treated with entacapone added to levodopa/carbodopa; there were "few clinically significant changes in liver function tests" and none of the 478 serious adverse events that were reported were due to hepatotoxicity).
Ebersbach G, Storch A. (2009). Tolcapone in elderly patients with Parkinson's disease: a prospective open-label multicenter non-interventional trial. Arch Gerontol Geriatr. (Among 237 patients with advanced Parkinson disease treated with tolcapone, diarrhea was the most common side effect [3.4%], ALT or AST elevations occurred in 18%, but were mostly mild and "not clinically significant").
McBurney RN, Hines WM, Von Tungeln LS, Schnackenberg LK, Beger RD, Moland CL, Han T, et al. (2009). The liver toxicity biomarker study: phase I design and preliminary results. Toxicol Pathol. (Design and early results of a comprehensive study of rats given 28 days of entacapone or tolcapone as examples of two related agents, one of which causes liver injury in man and one which does not, assessing liver enzymes, histology, gene transcription, proteomics, metabolomics and possible biomarkers to identify predictors of idiosyncratic liver injury in humans).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury but none were attributed to agents used for Parkinson disease).
Fischer JJ, Michaelis S, Schrey AK, Graebner OG, Glinski M, Dreger M, Kroll F, et al. (2010). Capture compound mass spectrometry sheds light on the molecular mechanisms of liver toxicity of two Parkinson drugs. Toxicol Sci. (In vitro study of binding of tolcapone and entacapone to other proteins; unlike entacapone, tolcapone interacted with a number of non-COMT intracellular proteins which are involved in the respiratory chain actions, fatty acid beta-oxidation and bile acid synthesis, perhaps accounting for its potential for hepatotoxicity).
Haasio K. (2010). Toxicology and safety of COMT inhibitors. Int Rev Neurobiol. (Extensive review of the mechanism of hepatic injury from tolcapone; "at the moment there is no explanation to the hepatotoxicity appeared in clinical use").
Marsala SZ, Gioulis M, Ceravolo R, Tinazzi M. (2012). A systematic review of catechol-0-methyltransferase inhibitors: efficacy and safety in clinical practice. Clin Neuropharmacol. (Systematic review of literature on safety and efficacy of tolcapone and entacapone recommends use of tolcapone only if entacapone treatment fails and liver tests are normal).
McBurney RN, Hines WM, VonTungeln LS, Schnackenberg LK, Beger RD, Moland CL, Han T, et al. (2012). The liver toxicity biomarker study phase I: markers for the effects of tolcapone or entacapone. Toxicol Pathol. (Comparison of the molecular effects of tolcapone vs entacapone on rat liver and plasma biomarkers found that changes from the two drugs only partially overlapped and different effects were present at 3 and 28 days, suggesting that some of these "off-target" and specific effects of tolcapone may account for its occasional hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to an agent used to treat Parkinson disease).
Drugs for Parkinson's disease. (2013). Treat Guidel Med Lett. (Concise review of recommendations for therapy of Parkinson disease with description of mechanisms of action, efficacy and adverse events).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an agent to treat Parkinson disease).
Eggert K, Oertel WH, Lees AJ. (2014). German Competence Network on Parkinson’s disease. Safety and efficacy of tolcapone in the long-term use in Parkinson disease: an observational study. Clin Neuropharmacol. (Among 391 patients with Parkinson disease treated with tolcapone in an observation study conducted at 48 neurologic centers and followed for one year, 34 [8.7%] developed liver enzyme elevation, usually within the first 3 months, which were above twice ULN in only 5 [1.3%] and resolved spontaneously in most; no patient developed clinically apparent liver injury).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, none were attributed to an agent used to treat Parkinson disease).
Longo DM, Yang Y, Watkins PB, Howell BA, Siler SQ. (2016). Elucidating differences in the hepatotoxic potential of tolcapone and entacapone with DILIsym(®), a mechanistic model of drug-induced liver injury. CPT Pharmacometrics Syst Pharmacol. (Description of mechanistic simulation models of the metabolism and toxicity of tolcapone and entacapone which predicted their differential hepatotoxicity).
Lv X, Wang XX, Hou J, Fang ZZ, Wu JJ, Cao YF, Liu SW, et al. (2016). Comparison of the inhibitory effects of tolcapone and entacapone against human UDP-glucuronosyl-transferases. Toxicol Appl Pharmacol. (Comparison of the inhibitory effects of tolacapone and entacapone against recombinant human UGTs showed more potent inhibition by tolacapone for most isoforms).
Drugs for Parkinson's disease. (2017). Med Lett Drugs Ther. (Concise review of medications approved for use in Parkinson disease including levodopa/carbidopa, dopamine agonists, MAO-B inhibitors, anticholinergics, and COMT inhibitors, mentions hepatotoxicity of tolcapone but not of levodopa or any of the other adjunctive therapies: “Use of tolcapone requires written informed consent and monitoring of liver function every 2-4 weeks for the first 6 months of treatment and periodically thereafter. Serious hepatoxicity has not been reported with entacapone”).
Margolesky J, Singer C. (2017). Extended-release oral capsule of carbidopa-levodopa in Parkinson disease. Ther Adv Neurol Disord. (Review of the pharmacology, efficacy and safety of extended release carbidopa/levodopa in listing of reported adverse reactions there is no mention of serious hepatic events or ALT elevations).
Mak A, Kato R, Weston K, Hayes A, Uetrecht J. (2018). Editor's highlight: An impaired immune tolerance animal model distinguishes the potential of troglitazone/pioglitazone and tolcapone/entacapone to cause IDILI. Toxicol Sci. (In an animal model of idiosyncratic liver injury using PD-1 knock out mice treated with anti-CTLA-4 to decrease the natural inhibition of T cell responses [immune check point], treatment with tolcapone caused greater injury than treatment with entacapone while neither agent caused liver injury in wild type mice or PD-1 knock out mice without anti-CTLA-4 treatment, suggesting that idiosyncratic liver injury is immune mediated, caused by an unregulated CD-8+ response and failure of immune tolerance).
Fremont R, Manoochehri M, Armstrong NM, Mattay VS, Apud JA, Tierney MC, Devanand DP, et al. (2020). Tolcapone treatment for cognitive and behavioral symptoms in behavioral variant frontotemporal dementia: a placebo-controlled crossover study. J Alzheimers Dis. (Among 28 adults with frontotemporal dementia with behavioral symptoms who were treated with tolcapone [200 mg] or placebo three times daily for 9 days in a cross-over design, tolcapone therapy was associated with slight improvements in some cognitive and behavioral scores and was well tolerated, although 21% of patients developed mild liver enzyme elevations [less than twice ULN] that were asymptomatic and resolved rapidly).
Artusi CA, Sarro L, Imbalzano G, Fabbri M, Lopiano L. (2021). Safety and efficacy of tolcapone in Parkinson's disease: systematic review. Eur J Clin Pharmacol. (Systematic review of the literature on the efficacy and safety of tolcapone identified 32 studies with 4780 patients, of whom 0.9% developed liver enzyme elevations above 2 times ULN; and while there were 3 case reports of fatal acute liver failure all reported in 1998, since then there have been no deaths and only 3 non-fatal cases).
Drugs for Parkinson's disease. (2021). Med Lett Drugs Ther. (Concise review of current medications approved for use in Parkinson disease including levodopa/carbidopa, dopamine agonists, COMT inhibitors, MAO-B inhibitors, anticholinergics, and istradefylline, mentions hepatotoxicity of tolcapone but not of levodopa or any of the adjunctive therapies).
Hauser RA, Hattori N, Fernandez H, Isaacson SH, Mochizuki H, Rascol O, Stocchi F, et al. (2021). Efficacy of istradefylline, an adenosine A2A receptor antagonist, as adjunctive therapy to levodopa in Parkinson's disease: a pooled analysis of 8 phase 2b/3 trials. J Parkinsons Dis. (In a pooled analysis of 8 randomized placebo-controlled trials of istradefylline in 2719 patients with Parkinson disease and motor complications, while adverse event rates were similar in the 3 groups [71% and 70% vs 65%] except for dyskinesia [16% and 18% vs 10%] and “no clinically meaningful changes in laboratory parameters…were observed” in any group including those on levodopa/carbidopa alone).

## OTHER REFERENCE LINKS

1 Recent References on Tolcapone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tolcapone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tolcapone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tolcapone)